# Propylthiouracil

## OVERVIEW

### Introduction

Propylthiouracil is an antithyroid medication used in the therapy of hyperthyroidism and Graves disease. Propylthiouracil has been linked to serum aminotransferase elevations during therapy as well as to a clinically apparent, idiosyncratic liver injury that can be severe and even fatal.

### Background

Propylthiouracil (proe" pil thye" oh ure' a sil) is a thioamide and a thyroid hormone antagonist which acts by inhibiting the incorporation of iodine into tyrosyl residues of thyroglobulin and thus lowering thyroid hormone levels. Propylthiouracil may also partially inhibit the peripheral deiodination of thyroxine [T4] to the active form [T3] and, in addition, may have immunosuppressive activities. Propylthiouracil was introduced into use in the 1940s and is still used for the temporary amelioration of hyperthyroidism in Graves disease in patients with mild or self-limited hyperthyroidism. However, because of the problems with hepatotoxicity including fatal cases of hepatitis, propylthiouracil is now considered a second line drug for hyperthyroidism, methimazole being preferred. Thus, propylthiouracil is currently used largely in patients who are intolerant to methimazole in preparation of definitive therapy or who wish to avoid thyroidectomy or radioactive iodine therapy. Propylthiouracil is also the preferred agent for medical therapy of hyperthyroidism in pregnancy, during the last trimester. Generic forms of propylthiouracil are available in 50 mg tablets. The usual dose in adults is 300 to 450 mg daily in divided doses until the patient is euthyroid, followed by a maintenance dose of 100 to 150 mg daily. Common side effects include gastrointestinal upset and rash. Rare complications of propylthiouracil (<1%) include agranulocytosis, aplastic anemia, nephritis and hepatitis.

### Hepatotoxicity

Propylthiouracil has been associated with transient, asymptomatic elevations in serum aminotransferase levels, typically during the first 3 months of therapy. These elevations are rarely clinically significant and usually resolve even with continuation of therapy. Propylthiouracil is also capable of causing clinically apparent, idiosyncratic liver injury at a rate estimated to be at least 1 per 1000 persons exposed. The onset of hepatotoxicity is usually within 2 to 12 weeks of starting, and the pattern of enzyme elevations is typically hepatocellular, although cholestatic and mixed patterns have also been described (Cases 1 to 3). In some cases, onset is months or more than a year after initiating therapy, sometimes shortly after dose modification. Rash, fever and eosinophilia are not uncommon, but are rarely prominent or severe. Some cases of propylthiouracil hepatotoxicity present with autoimmune features including antinuclear antibody and hyperglobulinemia, perhaps because of the background of autoimmune thyroid disease. While most patients start to improve with stopping therapy, many cases are severe and some have been associated with acute liver failure with death or need for emergency liver transplantation (Case 4). Liver injury from propylthiouracil appears to be more common and perhaps more severe in children and adolescents than in adults. Rates of acute liver failure due to propylthiouracil are estimated to be 1:10,000 in adults and as high as 1:2000 in children.

Complicating the assessment of the role of methimazole or propylthiouracil in causing liver injury is the fact that hyperthyroidism by itself can cause liver test abnormalities and even jaundice. Indeed, more than half of patients with untreated hyperthyroidism have serum enzyme abnormalities (usually less than 5 times the upper limit of the normal range) and a small proportion are jaundiced and present with cholestatic hepatitis. The liver test elevations are most frequent in patients with high output heart failure. The abnormalities resolve rapidly with treatment of hyperthyroidism either with surgery, radioactive iodine or antithyroid medications.

Likelihood score: A (well known cause of clinically apparent liver injury including acute liver failure)

### Mechanism of Injury

The mechanism by which propylthiouracil causes acute liver injury is unknown, but is likely due to an immunological reaction to a metabolic product of its metabolism. In several instances, positive results of lymphocyte stimulation to propylthiouracil have been reported. Complicating factors in assessing liver injury due to antithyroid medications is that hyperthyroidism itself can be associated with serum enzyme elevations and mild jaundice.

### Outcome and Management

The severity of propylthiouracil induced liver injury varies from mild, transient serum aminotransferase elevations to severe hepatitis, hepatic failure and death or need for liver transplantation. Fatal cases of hepatocellular injury arising months after starting therapy have been described, many in children. Some cases have features of autoimmunity or immunoallergic hepatitis and have been treated with corticosteroids, but without proven evidence of benefit. In most instances, however, recovery is rapid once propylthiouracil is stopped and the first priority should be immediate discontinuation of antithyroid therapy at the first sign of clinically apparent liver disease. The presence of hyperthyroidism may play a role in worsening liver function and temporary management with beta-blockers or other approaches may be necessary, even during the course of the acute liver injury. In some instances, patients with propylthiouracil induced liver injury have been switched to methimazole without evidence of recurrence. In severe cases, however, more definitive therapy of the hyperthyroidism with radioactive iodine or surgery is more appropriate.

Drug Class: Antithyroid Agents

Other Drugs in the Class: Methimazole

## CASE REPORTS

### Case 1. Mixed cholestatic-hepatocellular injury due to propylthiouracil.(1)

A 29 year old woman with Graves disease developed itching 4 weeks after starting propylthiouracil. On admission two weeks later, she was jaundiced with bilirubin 6.0 mg/dL, ALT 246 U/L and alkaline phosphatase 245 U/L (Table). Once propylthiouracil was stopped, she began to improve promptly.

#### Key Points

Medication: | Propylthiouracil (300 mg daily)
Pattern: | Mixed (R=2.9)
Severity: | 3+ jaundice and hospitalization)
Latency: | 4 weeks
Recovery: | 4 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 25 | 80 | 0.8
2 weeks | | 42 | 95 | 0.7
4 weeks | 0 | Propylthiouracil stopped | | | Itching and rash
6 weeks | 2 weeks | 246 | 245 | 6.0
7 weeks | 3 weeks | 250 | 145 | 5.3
8 weeks | 4 weeks | 215 | 102 | 2.8
10 weeks | 8 weeks | 150 | 105 | 0.9
12 weeks | 20 weeks | Normal | Normal | Normal
Normal Values | | <40 | <117 | <1.2

#### Comment

Typical, mild acute drug induced liver injury with a mixed pattern of serum enzyme elevations. Symptoms and liver test abnormalities worsened for 1 to 2 weeks after stopping therapy and then rapidly improved.

### Case 2. Acute hepatocellular injury due to propylthiouracil.(2)

A 22 year old woman with Graves disease developed jaundice, anorexia and pruritus 5 months after starting propylthiouracil [150 mg five times daily]. She had become pregnant shortly after starting propylthiouracil. She was taking no other medications and had no history of liver disease or risk factors for hepatitis. She denied fever and rash. On examination, she was jaundiced and had mild right upper quadrant tenderness. She had fullness in the thyroid area, a slight exophthalmic stare, mild tremor and hyperreflexia. Ultrasound confirmed the history of a 20 week pregnancy. Laboratory tests showed normal blood counts and coagulation tests. Her total serum bilirubin was 10.8 mg/dL (8.5 direct), AST 1385 U/L and Alk P 385 U/L. Propylthiouracil was stopped and her hyperthyroidism managed with propranolol. Liver test abnormalities rapidly improved (Table). Tests for hepatitis A and B were negative and abdominal ultrasound showed no evidence of biliary obstruction. Serum ALT and bilirubin levels fell to normal within 3 weeks. She tolerated switching to methimazole without recurrence. Lymphocyte stimulation tests were positive in response to propylthiouracil, but negative to methimazole during the acute illness.

#### Key Points

Medication: | Propylthiouracil (750 mg daily)
Pattern: | Hepatocellular (R=8.4, using AST instead of ALT)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 5 months
Recovery: | 3 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
5 months | 0 | 1385 | 385 | 10.8 | Admission
| 1 day | 1195 | 309 | 10.8
| 7 days | 465 | 226 | 3.5
| 9 days | 300 | 197 | 2.3
| 12 days | 176 | 162 | 1.5
| 16 days | 49 | 148 | 1.1
| 18 days | 35 | 155 | 0.9 | Methimazole started
| 20 days | 28 | 146 | 0.8
6 months | 25 days | 22 | 130 | 0.8
Normal Values | | <50 | <115 | <1.2

#### Comment

An example of acute hepatocellular injury due to propylthiouracil, with rapid recovery with stopping the medication and no recurrence on switching to methimazole. Management of hyperthyroidism during acute liver injury is problematic and generally requires control of the symptoms with beta blockers and delaying definitive therapy until there is some improvement in the liver injury.

### Case 3. Acute cholestatic hepatitis due to a short course of propylthiouracil.(3)

A 53 year old woman with hyperthyroidism and Graves disease was treated with propylthiouracil [50 mg three times daily] for 3 days and rapidly developed nausea, diarrhea, pruritus, and abdominal pain followed by dark urine and jaundice. Although propylthiouracil was stopped promptly, she continued to be symptomatic and liver tests worsened (Table). On admission 9 days after starting and 6 days after stopping propylthiouracil, she was afebrile but deeply icteric. She had a mild tremor, bilateral exophthalmos and a small diffuse goiter which were unchanged from before. She had no hepatomegaly or signs of chronic liver disease. Laboratory tests showed ALT 83 U/L, Alk P 371 U/L and total serum bilirubin 7.9 mg/dL. The total eosinophil count was 640/µL. Tests for hepatitis A, B and C were negative as were antinuclear and antismooth muscle antibodies. Abdominal ultrasound showed no evidence of biliary obstruction. A liver biopsy showed marked cholestasis, focal necrosis and portal inflammation with eosinophils, compatible with drug induced liver injury. Lymphocyte stimulation tests in response to propylthiouracil were negative on two occasions. Her thyroid disease was treated with radioactive iodine. Her jaundice deepened during the first two weeks of hospitalization with serum bilirubin peaking at 40.8 mg/dL. Thereafter she improved and, in follow up 6 weeks later, she was asymptomatic and anicteric. However, minor liver test abnormalities persisted for several years. A second liver biopsy was read as normal. Five years after exposure, all enzyme levels were normal.

#### Key Points

Medication: | Propylthiouracil (150 mg daily for 3 days)
Pattern: | Cholestatic (R=0.8)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 3 days
Recovery: | 6 weeks for jaundice, >2 years for serum enzymes
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | 19 | 80 | <0.5
5 days | 119 | 289
9 days | 83 | 371 | 7.9 | Admission
15 days | 58 | 354 | 30.0
22 days | 64 | 317 | 40.8
26 days | 61 | 280 | 34.2 | Liver biopsy
2 months | 64 | 353 | 2.1 | Asymptomatic
2 years | 30 | 116 | <1.0
3 years | 33 | 88 | <1.0 | Liver biopsy
4 years | 38 | 131 | <1.0
5 years | 28 | 123 | <1.0
6 years | 24 | 94 | <1.0
Normal Values | <25 | <90 | <1.2

#### Comment

This case was unusual because of the short latency period and prolonged cholestatic course in response to only 3 days of propylthiouracil therapy. The patient denied taking propylthiouracil or similar medications previously. Other diagnoses were excluded and liver histology supported the diagnosis of propylthiouracil induced cholestatic liver injury. The persistent liver test abnormalities suggested chronic injury, but this was not documented by the liver biopsy. The residual minor enzyme elevations may have been unrelated to the drug induced liver injury.

### Case 4. Acute liver failure due to propylthiouracil.(4)

A 14 year old girl with Graves disease, exophthalmos and goiter was treated with methimazole with gradual improvement, but relapsed when it was stopped after 3 months. One week after switching to propylthiouracil (450 mg daily), she developed fatigue, vomiting and diarrhea followed by dark urine and jaundice. She remained symptomatic of her thyroid disease with tachycardia and tremor. On examination, she was jaundiced, but did not have fever, rash or signs of chronic liver disease. Laboratory tests showed bilirubin of 13.2 mg/dL and marked elevations of serum ALT (1501 U/L) and AST (2800 U/L) with minimal increase in alkaline phosphatase (287 U/L). Propylthiouracil was stopped and she was maintained on propranolol. Because of worsening liver failure, she was transferred to a tertiary medical center. Tests for hepatitis A, B and C were negative as were antinuclear and smooth muscle antibodies. Thyroid studies showed a normal total and free thyroxine level. An open liver biopsy showed massive necrosis, and she underwent successful liver transplantation 10 days after onset of liver injury and 19 days after starting propylthiouracil.

#### Key Points

Medication: | Propylthiouracil (450 mg daily)
Pattern: | Hepatocellular (R=56)
Severity: | 5+ (emergency liver transplant)
Latency: | 1 week
Recovery: | None
Other medications: | Propranolol

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre (-60) | | 68 | 256 | 0.5 | Thyrotoxicosis
0 | | Propylthiouracil (450 mg daily) started
8 | 0 | 2501 | | 13.2 | Drugs stopped
17 | 9 | | | 16.2
18 | 10 | 770 | 287 | 22.0
19 | 11 | Emergency liver transplantation
Normal Values | | <45 | <140 | <1.2

#### Comment

More than two dozen cases of acute liver failure attributable to propylthiouracil therapy have been reported in the literature, with several cases occurring in children or adolescents. This severe outcome has led to the recommendation that propylthiouracil not be used in children and not be considered as a first line of therapy for Graves disease in adults. The injury is typically hepatocellular and associated with rapid development of acute liver failure and death. The latency to onset can be short as in this instance (one week) or prolonged to as long as a year. This patient recovered after liver transplantation and was later treated successfully with subtotal thyroidectomy.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Propylthiouracil – Generic

DRUG CLASS

Antithyroid Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Propylthiouracil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Propylthiouracil | 51-52-5 | C7-H10-N2-O-S

## CITED REFERENCES

1 Kim HJ, Kim BH, Han YS, Yang I, Kim KJ, Dong SH, et al. (2001). The incidence and clinical characteristics of symptomatic propylthiouracil-induced hepatic injury in patients with hyperthyroidism: a single-center retrospective study. Am J Gastroenterol.
2 Parker WA. (1982). Propylthiouracil-induced hepatotoxicity. Clin Pharm.
3 Lock DR, Sthoeger ZM. (1997). Severe hepatotoxicity on beginning propylthiouracil therapy. J Clin Gastroenterol.
4 Williams KV, Nayak S, Becker D, Reyes J, Burmeister LA. (1997). Fifty years of experience with propylthiouracil-associated hepatotoxicity: what have we learned?. J Clin Endocrinol Metab.

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2020

Zimmerman HJ. Antithyroid drugs. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 579-81. (Expert review of hepatotoxicity of antithyroid medications published in 1999; mentions 35 recorded cases of jaundice attributed to propylthiouracil [usually hepatocellular] and 15 to methimazole [usually cholestatic]).
Chitturi S, Farrell GC. Antithyroid drugs. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 614-5. (Review of hepatotoxicity of antithyroid agents mentions that propylthiouracil can cause severe acute hepatitis and death from acute liver failure).
Brent GA, Koenig RJ. Thyroid and anti-thyroid drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 787-802. (Textbook of pharmacology and therapeutics).
Livingston HJ, Livingston SF. (1947). Agranulocytosis and hepatocellular jaundice: toxic reactions following propylthiouracil therapy. JAMA. (68 year old man developed fever and malaise 6 weeks after starting propylthiouracil [200 mg/day] with leucopenia and jaundice, recovering with antibiotics and withdrawal of propylthiouracil, but details not provided).
Juliar B, Harris TL. (1949). Fatal agranulocytosis occurring during propylthiouracil therapy: report of a case. JAMA. (25 year old woman developed fever, rash and agranulocytosis after several months of propylthiouracil, with progressive delirium and jaundice a few days before death).
McCormick RV. (1950). Polyarteritis occurring during propylthiouracil therapy. JAMA. (Elderly woman developed fever and diarrhea within 24 hours of restarting propylthiouracil, improving on withdrawal and recurring with a single rechallenge dose; later inadvertent reexposure led to fever, delirium, stroke and death; autopsy showed polyarteritis).
Specht NW, Boehme EJ. (1952). Death due to agranulocytosis induced by methimazole therapy. JAMA. (67 year old woman developed fever 4 weeks after starting methimazole with agranulocytosis and jaundice, dying within 1-2 days, liver at autopsy showing “central congestion”).
Colwell AR, Sando DE, Lang SJ. (1952). Propylthiouracil-induced agranulocytosis, toxic hepatitis, and death. JAMA. (60 year old woman with heart disease and arrhythmias developed fever and cough 1 month after starting propylthiouracil with pancytopenia followed by jaundice [bilirubin 10.9 mg/dL, normal Alk P] and death 3 days later, autopsy showing severe centrolobular necrosis).
Eisen MJ. (1953). Fulminant hepatitis during treatment with propylthiouracil. N Engl J Med. (52 year old woman developed severe abdominal pain and nausea within 1 day of starting propylthiouracil and died 4 days later in shock but without jaundice; autopsy showed severe centrolobular hepatic necrosis interpreted as an acute hepatitis).
Rosenbaum H, Reveno WS. (1953). Agranulocytosis and toxic hepatitis from methimazole. JAMA. (62 year old woman developed jaundice 7 weeks after starting methimazole followed by agranulocytosis, resolving rapidly with stopping methimazole; had tolerated propylthiouracil).
Shipp JC. (1955). Jaundice during methimazole (‘Tapazole’) administration. Ann Intern Med. (63 year old woman developed pruritus followed by jaundice 2 weeks after starting methimazole [bilirubin 8.7 mg/dL, Alk P 3 times ULN], with subsequent worsening of jaundice and agranulocytosis responding to antibiotics; resolution of jaundice in 10 weeks).
Tennenbaum JI, Dreskin OH. (1962). Toxic hepatitis during treatment with methimazole (Tapazole). Report of a case with apparent recovery. Ohio Med J. (38 year old woman developed rash, jaundice and pruritus ~4 weeks after starting methimazole [bilirubin 6.2 mg/dL, ALT 545 U/L, Alk P ~2 times ULN, 12% eosinophils], slowly resolving on stopping therapy).
Martinez-Lopez JI, Greenberg SE, Kling RR. (1962). Drug-induced hepatic injury during methimazole therapy. Gastroenterology. (36 year old woman developed jaundice and pruritus 1 month after starting methimazole [bilirubin 18 m/dL, Alk P 3 times ULN, AST 400 U/L, protime 18 sec]; delay in stopping methimazole and jaundice persisted for 10 weeks).
Greenberger NJ, Milligan FD, DeGroot LJ, Isselbacher KJ. (1964). Jaundice and thyrotoxicosis in the absence of congestive heart failure. A study of four cases. Am J Med. (4 patients, 2 men and 2 women, ages 20 to 51 years had jaundice and hyperthyroidism without congestive heart failure or other known causes of liver disease [bilirubin 1.3-6.4 mg/dL, Alk P 1-3 times ULN, AST 13-40 U/L], jaundice resolving with therapy of hyperthyroidism).
Sambe K. (1965). Liver injury due to drugs. Acta Hepatol (Japan). (Review of pathology of 19 cases of drug induced liver disease; one due to methylthiouracil [similar to propylthiouracil, not used in US] and one to mercazol [carbimazole]; little clinical information given).
Becker CE, Gorden P, Robbins J. (1968). Hepatitis from methimazole during adrenal steroid therapy for malignant exophthalmos. JAMA. (54 year old woman on corticosteroids for severe exophthalmos developed jaundice 4 weeks after starting methimazole [bilirubin 5.1 mg/dL, ALT 414 U/L, Alk P 1.5 times ULN]; switched to propylthiouracil and recovered promptly).
Amrhein JA, Kenny FM, Rose D. (1970). Granulocytopenia, lupus-like syndrome and other complications of propylthiouracil therapy. J Pediatr. (38 children treated with propylthiouracil were followed prospectively; 10 developed transient leucopenia, one a lupus-like syndrome, 4 urticaria, 2 rash and 2 drug fever; no clinically apparent liver disease).
Fischer MG, Nayer HR, Miller A. (1973). Methimazole-induced jaundice. JAMA. (74 year old woman developed jaundice 2 weeks after starting methimazole [bilirubin 13.6 mg/dL, Alk P 270 U/L, ALT 96 U/L]; jaundice lasted 2 months after stopping, even with prednisone therapy).
Ishizuki Y. (1974). Horumon To Rinsho. (Two cases, ages 62 and 75 years, with onset of jaundice 3 and 5 weeks after starting antithyroid therapy, with prolonged cholestasis in patient in whom methimazole was continued).
Parker LN. (1975). Hepatitis and propylthiouracil. Ann Intern Med. (9 year old girl with Graves disease developed jaundice 2 months after starting propylthiouracil [bilirubin 48 mg/dL, AST 2524 U/L; protime 35 sec, ammonia elevated], resolving within 10 weeks of stopping; lymphocyte stimulation test negative).
Fedotin MS, Lefer LG. (1975). Liver disease caused by propylthiouracil. Arch Intern Med. (56 year old man developed liver test abnormalities within a short but undefined time after starting propylthiouracil [bilirubin 2.1 mg/dL, ALT 238 U/L, Alk P 395 U/L], biopsy showing chronic hepatitis with portal inflammation and fibrosis; resolving rapidly upon stopping).
Mihas AA, Holley P, Koff RS, Hirschowitz BI. (1976). Fulminant hepatitis and lymphocyte sensitization due to propylthiouracil. Gastroenterology. (34 year old woman developed jaundice 2-3 months after starting propylthiouracil which was continued until she became disoriented [bilirubin 20.7 mg/dL, ALT 1060 U/L, Alk P 274 U/L, protime 24.1 sec], resolving spontaneously; positive lymphocyte stimulation to propylthiouracil, biopsy showed bridging necrosis).
Maddrey WC, Boitnott JK. (1977). Drug-induced chronic liver disease. Gastroenterology. (Review of drugs that cause chronic hepatitis; oxyphenisatin, isoniazid, methyldopa, nitrofurantoin, phenothiazines; mentioning 2 cases with bridging necrosis associated with propylthiouracil).
Reddy CM. (1979). Propylthiouracil and hepatitis: a case report. J Natl Med Assoc. (10 year old girl with Hashimotos thyroiditis developed jaundice 23 days after starting propylthiouracil [bilirubin 10.5 mg/dL, AST 350 U/L, Alk P 400 U/L], resolving rapidly upon stopping therapy).
Jacobsen BB. (1979). Ugeskr Laeger.
Nielsen HK, Iversen TO. (1980). Ugeskr Laeger.
Weiss M, Hassin D, Bank H. (1980). Propylthiouracil-induced hepatic damage. Arch Intern Med. (Two cases; 28 year old woman developed jaundice 5 months after starting propylthiouracil [bilirubin 7.2 mg/dL, AST 250 U/L, Alk P normal], resolving in 2 months and recurring upon rechallenge, but then tolerating methimazole; 54 year old woman developed jaundice and pruritus 5 months after restarting propylthiouracil [bilirubin 2.4 mg/dL, AST 60 U/L, Alk P 220 U/L], with slow, incomplete recovery on stopping and biopsy later showing cirrhosis).
Pacini F, Sridama V, Refetoff S. (1982). Multiple complications of propylthiouracil treatment: granulocytopenia, eosinophilia, skin reaction and hepatitis with lymphocyte sensitization. J Endocrinol Invest. (47 year old woman developed rash, fever and eosinophilia 4 weeks after starting propylthiouracil [bilirubin 3.5 mg/dL, AST 276 U/L, Alk P 588 U/L, neutropenia], with reversal on stopping propylthiouracil, positive lymphocyte stimulation test in immediate period of withdrawal).
Parker WA. (1982). Propylthiouracil-induced hepatotoxicity. Clin Pharm. (22 year old woman developed jaundice and pruritus 5 months after starting propylthiouracil [bilirubin 10.8 mg/dL, AST 1385 U/L, Alk P 385 U/L], resolving within 3 weeks; patient switched to methimazole without recurrence: Case 2).
Kimura T, Shindo T. (1982). Nippon Naika Gakkai Zasshi. (Randomized, placebo controlled trial of propylthiouracil [300 mg daily for 6 weeks] in 67 patients with acute alcoholic hepatitis; no difference in survival or time to improvement of any liver test abnormalities or symptoms; side effects of hypothyroidism, but no apparent hepatotoxicity).
Safani MM, Tatro DS, Rudd P. (1982). Fatal propylthiouracil-induced hepatitis. Arch Intern Med. (20 year old woman developed fatigue and jaundice 2 weeks after starting propylthiouracil [bilirubin 22 mg/dL, AST 750 U/L, Alk P 248 U/L], with progressive hepatic failure, dying 4 months later).
Cooper DS. (1984). Antithyroid drugs. N Engl J Med. (Extensive review of mechanism of action, efficacy and safety of propylthiouracil and methimazole in treating hyperthyroidism; side effects occur in 1-5% of patients, including fever, rash, urticaria, transient leucopenia, and arthralgias particularly with higher doses; severe side effects include agranulocytosis, vasculitis, aplastic anemia, thrombocytopenia and nephritic syndrome).
Hanson JS. (1984). Propylthiouracil and hepatitis. Two cases and a review of the literature. Arch Intern Med. (Two 20 year old women developed jaundice 3 months after starting propylthiouracil [bilirubin 11.4 and 24.6 mg/dL, AST 714 and 1260 U/L, Alk P 119 and 44 U/L], one progressing to liver failure and death, the other recovering within 6 weeks of stopping).
Bloch CA, Jenski LJ, Balistreri WF, Dolan LM. (1985). Propylthiouracil-associated hepatitis. Arch Intern Med. (12 year old boy developed jaundice 2 months after starting propylthiouracil [bilirubin 5.5 mg/dL, ALT 1716 U/L, Alk P 4 times ULN], resolving within 1 month of stopping; negative lymphocyte stimulation tests).
Garty BZ, Kauli R, Ben-Ari J, Lubin E, Nitzan M, Laron Z. (1985). Hepatitis associated with propylthiouracil treatment. Drug Intell Clin Pharm. (12 year old girl developed urticarial rash 3 days after starting propylthiouracil and diarrhea and fever 2 days after restarting [bilirubin 4.2 mg/dL, AST 230 U/L, Alk P 350 U/L], tests improving within a week of stopping).
Vitug AC, Goldman JM. (1985). Hepatotoxicity from antithyroid drugs. Horm Res. (Review of literature identified 29 cases of hepatic injury due to antithyroid drugs; propylthiouracil [n=17], methimazole [n=10] and carbimazole [n=3]; propylthiouracil cases were primarily hepatocellular with onset in 10 days to 5 months; the other drugs caused cholestatic injury, arising after 10 days to 8 weeks).
Cofré C, Valdés E, Tapia A, Rodríguez J. (1986). Rev Med Chil. (58 year old developed abdominal pain 18 days after starting methimazole [bilirubin 1.2 mg/dL, ALT 93 U/L, Alk P 572 U/L], with improvement on stopping and recurrent rise in Alk P with rechallenge).
Seidman DS, Livni E, Ilie B, Blum I. (1986). Propylthiouracil-induced cholestatic jaundice. J Toxicol Clin Toxicol. (33 year old woman developed pruritus and jaundice 2 weeks after starting propylthiouracil [bilirubin 13.2 mg/dL, ALT 27 U/L, Alk P 339 U/L], resolving within 4 weeks of stopping; positive macrophage migration inhibition test to propylthiouracil).
Limaye A, Ruffolo PR. (1987). Propylthiouracil-induced fatal hepatic necrosis. Am J Gastroenterol. (42 year old woman developed jaundice 1 year after starting propylthiouracil [bilirubin 22 mg/dL, AST 1755 U/L, Alk P 381 U/L, protime 21 sec], progressing to hepatic failure and death within 4 days; autopsy showed massive necrosis without fibrosis).
Jonas MM, Eidson MS. (1988). Propylthiouracil hepatotoxicity: two pediatric cases and review of the literature. J Pediatr Gastroenterol Nutr. (Two cases; 6 year old girl developed jaundice 4 months after starting propylthiouracil 300 mg/day [bilirubin 11.9 mg/dL, ALT 999 U/L, ANA 1:320], improving rapidly upon stopping; 13 year old girl developed jaundice and pruritus 7 months after starting propylthiouracil 300 mg/day [bilirubin 14.7 mg/dL, ALT 1530 U/L, Alk P 369 U/L, ANA 1:160], progressing to liver failure before stopping drug and dying 9 days later, autopsy showing massive necrosis).
Yao JD, Gross JB, Ludwig J, Purnell DC. (1989). Cholestatic jaundice in hyperthyroidism. Am J Med. (42 year old man presented with jaundice and weight loss [bilirubin 16.7 rising to 36.0 mg/dL, ALT 76 U/L, Alk P 252 U/L], biopsy showed intrahepatic cholestasis, found to have hyperthyroidism, jaundice resolving with radioactive iodine therapy).
Maggiore G, Larizza D, Lorini R, De Giacomo C, Scotta MS, Severi F. (1989). Propylthiouracil hepatotoxicity mimicking autoimmune chronic active hepatitis in a girl. J Pediatr Gastroenterol Nutr. (8 year old was found to have hepatomegaly 12 months after starting propylthiouracil [bilirubin normal, ALT 765 U/L, GGT 3 times ULN], biopsy showing chronic hepatitis; ANA negative but antithyroid antibodies present; rapid resolution on stopping drug and later tolerating methimazole).
Baker B, Shapiro B, Fig LM, Woodbury D, Sisson JC, Beierwaltes WH. (1989). Unusual complications of antithyroid drug therapy: four case reports and review of literature. Thyroidology. (3 cases of hepatotoxicity; 34 year old woman developed jaundice 6 months after starting propylthiouracil [bilirubin 20.6 mg/dL, ALT 957 U/L, Alk P 176 U/L], delayed withdrawal and slow recovery; 9 year old girl developed jaundice 3 months after starting propylthiouracil [bilirubin 9.0 mg/dL, ALT 1407 U/L, Alk P 848 U/L], resolving rapidly upon stopping; 20 year old woman developed jaundice 8 months after starting methimazole [bilirubin 27 mg/dL, ALT 2040 U/L, Alk P 389 U/L], progressing to hepatic failure and death, autopsy showing massive necrosis).
Werner MC, Romaldini JH, Bromberg N, Werner RS, Farah CS. (1989). Adverse effects related to thioamide drugs and their dose regimen. Am J Med Sci. (Among 389 patients with Graves disease, 5 had hepatotoxicity on antithyroid therapy, 4 of 131 [2%] on propylthiouracil vs 1 of 258 [0.5%] on methimazole, all recovered; liver injury typically arose during initial high dose therapy).
Kirkland JL. (1990). Propylthiouracil-induced hepatic failure and encephalopathy in a child. DICP. (9 year old girl developed jaundice and delirium 4 months after starting propylthiouracil [bilirubin 14 mg/dL, AST 1215 U/L, protime 27.5 sec], but recovering ultimately after stopping medication).
Kang H, Choi JD, Jung IG, Kim DW, Kim TB, Shin HK, Kim BT, Park CK, Yoo JY. (1990). A case of methimazole-induced acute hepatic failure in a patient with chronic hepatitis B carrier. Korean J Intern Med. (43 year old man with HBsAg carrier state developed jaundice 7 months after starting methimazole [bilirubin 5.0 mg/dL, ALT 180 U/L, Alk P 848 U/L, no detectable HBV DNA], developed worsening hepatic failure and died 30 days after admission, autopsy showing cirrhosis with severe cholestasis).
Di Gregorio C, Ghini F, Rivasi F. (1990). Granulomatous hepatitis in a patient receiving methimazole. Ital J Gastroenterol. (56 year old woman developed abnormal liver tests 11 years after starting methimazole and not resolving when drug was stopped, biopsy showing active granulomas with giant cells suggestive of sarcoidosis [bilirubin normal, ALT 51-139 U/L, Alk P 484-652 U/L]).
Findor J, Bruch Igartúa E, Sorda J, Jury R. (1991). Acta Gastroenterol Latinoam. (Four patients with thyrotoxicosis and “cholestasis” [bilirubin 0.8-1.0 mg/dL, Alk P 300-548 U/L, GGT 17-166 U/L], biopsies showing intrahepatic cholestasis).
Hayashida CY, Duarte AJ, Sato AE, Yamoshuro-Kanasbiro EH. (1991). Neonatal hepatitis and lymphocyte sensitization by placental transfer of propylthiouracil. J Endocrinol Invest. (Female newborn of a mother taking propylthiouracil had hyperthyroidism and liver injury [bilirubin 14 mg/dL, ALT 110 U/L, Alk P 2 times ULN], resolving spontaneously; positive lymphocyte stimulation test).
Peter SA. (1991). Propylthiouracil-associated hepatitis. J Natl Med Assoc. (43 year old woman developed jaundice 10 weeks after starting propylthiouracil [bilirubin 6.4 mg/dL, AST 926 U/L, Alk P 292 U/L], worsening for 10 days and then resolving within 10 weeks of stopping).
Fong TL, McHutchison JG, Reynolds TB. (1992). Hyperthyroidism and hepatic dysfunction. A case series analysis. J Clin Gastroenterol. (Among 18 patients with hyperthyroidism not on antithyroid therapy, 50% had bilirubin elevations [2 were deeply jaundiced] and 67% ALT elevations; highest rates present in those with heart failure due to hyperthyroidism).
Frenkel J, Téllez R, Reyes C, González G, Michaud P. (1993). Rev Med Chil. (60 patients with hyperthyroidism and normal baseline ALT levels were monitored on propylthiouracil, 28% had ALT elevations [40-231 U/L] all within 2 months and on initial dosage [300 mg/day], falling to normal with continuation [100 mg/day]; no symptoms, jaundice or Alk P elevations; liver biopsies in 3 patients showed spotty necrosis and ill-defined granulomas).
Liaw YF, Huang MJ, Fan KD, Li KL, Wu SS, Chen TJ. (1993). Hepatic injury during propylthiouracil therapy in patients with hyperthyroidism. A cohort study. Ann Intern Med. (60 patients with hyperthyroidism and normal baseline ALT levels were monitored on propylthiouracil, 28% developed ALT elevations [40-231 U/L] all within 2 months of starting initial high dosage [300 mg/day], falling to normal with continuation [100 mg/day]; no symptoms, jaundice or Alk P elevations; liver biopsies in 3 patients showed spotty necrosis and ill defined granulomas).
Sadoul JL, Canivet B, Freychet P. (1993). Toxic hepatitis induced by antithyroid drugs: four cases including one with cross-reactivity between carbimazole and benzylthiouracil. Eur J Med. (Retrospective analysis of 236 patients with hyperthyroidism treated at one center found 4 cases [1.7%] with hepatotoxicity due to carbimazole; only one with jaundice [bilirubin 3.5 mg/dL, ALT 162 U/L, Alk P 318 U/L], resolving within 4 weeks of stopping; other cases were anicteric and associated with drug-fever or rash, largely cholestatic enzyme patterns).
Levy M. (1993). Propylthiouracil hepatotoxicity. A review and case presentation. Clin Pediatr (Phila). (14 year old girl developed jaundice 14 months after starting propylthiouracil with severe course, hepatic failure but ultimate slow recovery).
Westphal SA. (1994). Hepatotoxicity from propylthiouracil. South Med J. (32 year old woman developed jaundice 2.5 months after switching from methimazole to propylthiouracil [bilirubin 9.5 mg/dL, ALT 2030 U/L, Alk P ~250 U/L], resolving within 4 months of stopping).
Huang MJ, Li KL, Wei JS, Wu SS, Fan KD, Liaw YF. (1994). Sequential liver and bone biochemical changes in hyperthyroidism: prospective controlled follow-up study. Am J Gastroenterol. (Prospective study of 95 patients with hyperthyroidism treated with propylthiouracil; 76% had at least one liver test abnormality before therapy, 37% in ALT [peak 169 U/L] and 64% in Alk P [peak 337 U/L]; ALT levels often decreased with treatment, but rose further in 38%, one developing jaundice [ALT 1490 U/L], resolving with stopping therapy).
Hoffman DM, Burgess J, Hill P. (1994). Agranulocytosis and hepatic dysfunction following propylthiouracil treatment. Aust N Z J Med. (55 year old woman developed pruritus, jaundice and fever 6 weeks after starting propylthiouracil [bilirubin 17.4 mg/dL, ALT 165 U/L, Alk P 340 U/L, ANA positive], with agranulocytosis resolving within 3 months of stopping drug).
Mamianetti A, Muñoz A, Ronchetti RD, Maccione E, Poggi U, Mugnolo R, et al. (1995). Medicina (B Aires). (62 year old woman developed jaundice and pruritus within 10 days of starting methimazole [bilirubin 16 rising to 39 mg/dL, ALT 65 U/L, Alk P 670 U/L], with prolonged jaundice and sideroblastic anemia, resolving slowing with normal tests 14 months later).
Arab DM, Malatjalian DA, Rittmaster RS. (1995). Severe cholestatic jaundice in uncomplicated hyperthyroidism treated with methimazole. J Clin Endocrinol Metab. (48 year old man with hyperthyroidism and mild liver test abnormalities developed jaundice and worsening pruritus 1 month after starting methimazole [bilirubin 30.1 mg/dL, AST 40 U/L, Alk P 475 U/L], improving with stopping methimazole and achieving euthyroidism with radioactive iodide).
Singh A, Thakur R. (1995). Scintigraphic study of propylthiouracil induced submassive hepatic necrosis. Clin Nucl Med. (44 year old woman developed nausea and vomiting 11 months after starting propylthiouracil [bilirubin 2.4 mg/dL, ALT 2610 U/L, Alk P 357 U/L, protime 13.7 sec, ANA 1: 1280], resolving on stopping; liver scans showing decreased uptake during episode).
Deidiker R, deMello DE. (1996). Propylthiouracil-induced fulminant hepatitis: case report and review of the literature. Pediatr Pathol Lab Med. (13 year old girl developed jaundice 4 months after starting propylthiouracil [bilirubin 13.8 mg/dL, ALT 1716 U/L, Alk P not given, ANA 1:20], worsening and undergoing liver transplantation within 7 days, but dying postoperatively, explant showing massive necrosis and collapse).
Schwab GP, Wetscher GJ, Vogl W, Redmond E. (1996). Methimazole-induced cholestatic liver injury, mimicking sclerosing cholangitis. Langenbecks Arch Chir. (68 year old man developed jaundice and pruritus 2 months after starting methimazole [bilirubin 3.1 rising to 12.2 mg/dL, ALT 61 U/L, Alk P 530 U/L], resolving within 3 months of stopping and with thyroidectomy).
Hardee JT, Barnett AL, Thannoun A, Eghtesad B, Wheeler D, Jamal MM. (1996). Propylthiouracil-induced hepatotoxicity. West J Med. (37 year old woman developed jaundice 5 months after starting propylthiouracil [bilirubin 16.6 mg/dL, ALT 1135 U/L, Alk P 486 U/L, ANA 1:320, SMA 1:40, protime rising to 21.4 sec], with signs of hepatic failure, biopsy showing bridging necrosis, responding to support and prednisone, ultimately recovering).
Ozenírler S, Tuncer C, Boztepe U, Akyol G, Alkim H, Cakir N, et al. (1996). Propylthiouracil-induced hepatic damage. Ann Pharmacother. (64 year old woman developed jaundice 1 year after starting propylthiouracil [bilirubin 7.3 mg/dL, ALT 990 U/L, Alk P 123 U/L, protime 20 sec, ANA negative], slow resolution and biopsy showing bridging necrosis; a year later, she had continued enzyme elevations and evidence of cirrhosis [ascites and splenomegaly]).
Williams KV, Nayak S, Becker D, Reyes J, Burmeister LA. (1997). Fifty years of experience with propylthiouracil-associated hepatotoxicity: what have we learned?. J Clin Endocrinol Metab. (Two cases; 14 year old girl developed jaundice 3 weeks after restarting propylthiouracil [bilirubin 13.2 mg/dL, ALT 2501 U/L, Alk P 287 U/L], progressing to hepatic failure and successful liver transplant, explant showing massive necrosis [Case 4]; 54 year old man with thyrotoxicosis and liver test abnormalities developed jaundice 2 weeks after starting propylthiouracil [bilirubin 5.8 to 23.5 mg/dL, ALT 740 U/L, Alk P 258 U/L], with progressive hepatic failure and death 5 weeks later; review of literature found 28 cases of propylthiouracil hepatotoxicity, 25 in women, 7 fatal).
Lock DR, Sthoeger ZM. (1997). Severe hepatotoxicity on beginning propylthiouracil therapy. J Clin Gastroenterol. (53 year old woman developed jaundice after only 3 days of propylthiouracil [bilirubin 7.9 rising to 40.8 mg/dL, ALT 83 U/L, Alk P 371 U/L], with clinical improvement within 6 weeks of stopping, but mild liver enzyme abnormalities persisting for more than 2 years: Case 3).
Gürlek A, Cobankara V, Bayraktar M. (1997). Liver tests in hyperthyroidism: effect of antithyroid therapy. J Clin Gastroenterol. (At least one liver test abnormality found in 60% of patients with hyperthyroidism before therapy; Alk P in 44% and ALT in 23% and GGT, often improving on propylthiouracil therapy, but 15% developed de novo ALT elevations by 6 weeks, none were symptomatic, jaundiced or required dose modification).
Khovidhunkit W, Farese RV. (1997). Resolution of propylthiouracil-induced hepatic failure after treatment of thyrotoxicosis. West J Med. (21 year old woman with severe hyperthyroidism and liver test abnormalities developed jaundice 4 months after starting propylthiouracil [bilirubin 15.0 mg/dL, ALT 942 U/L, Alk P 205 U/L], not improving during first month after stopping, but then resolving with treatment of hyperthyroidism).
Ichiki Y, Akahoshi M, Yamashita N, Morita C, Maruyama T, Horiuchi T, et al. (1998). Propylthiouracil-induced severe hepatitis: a case report and review of the literature. J Gastroenterol. (21 year old woman developed nausea 2 months after starting propylthiouracil [bilirubin 23.2 mg/L, ALT 502 U/L, Alk P 1442 U/L], resolving within 6 weeks on prednisolone; positive lymphocyte stimulation test; review of literature includes 25 cases with 5 fatalities).
Waseem M, Seshadri KG, Kabadi UM. (1998). Successful outcome with methimazole and lithium combination therapy for propylthiouracil-induced hepatotoxicity. Endocr Pract. (49 year old man developed nausea 2 months and jaundice 4 months after starting propylthiouracil [bilirubin 20.4 mg/dL, ALT 1043 U/L, Alk P 186 U/L], values worsening for 1 month despite stopping and then slowly returning towards normal while on methimazole).
Hung YT, Yu WK, Chow E. (1999). Delayed cholestatic hepatitis due to methimazole. Hong Kong Med J. (71 year old man developed jaundice a few weeks after stopping a 5 month course of methimazole with prolonged jaundice [bilirubin 40 mg/dL, ALT 40 U/L, Alk P 600 U/L], with slow recovery over more than 6 months).
Babini G, Gurioli L, Rizzi R, Bertello P. (1999). Appearance of severe jaundice after radiometabolical treatment of thyrotoxicosis. J Endocrinol Invest. (63 year old man developed jaundice 2 weeks after receiving radioactive iodine for toxic goiter [bilirubin 6.8 mg/dL, ALT 86, Alk P 426 U/L], worsening for 2 weeks and then slowly improving and tolerating methimazole).
Parolin MB, Lopes RW, Telles JE, Ioshii SO, Hajar N. (2000). Arq Gastroenterol.
De Castro JJ, Nobre EL, Garcia e Costa J, Galvão-Teles A. (2001). Acta Med Port.
Kim HJ, Kim BH, Han YS, Yang I, Kim KJ, Dong SH, et al. (2001). The incidence and clinical characteristics of symptomatic propylthiouracil-induced hepatic injury in patients with hyperthyroidism: a single-center retrospective study. Am J Gastroenterol. (Retrospective analysis of 497 patients with hyperthyroidism treated with propylthiouracil; 6 [1.2%] developed clinically apparent hepatotoxicity 12 to 49 days after starting; 5 were jaundiced [peak bilirubin 0.5-42.7 mg/dL, ALT 33-296 U/L, Alk P 132-373 U/L], no autoantibodies, 2 with rash; 3 cholestatic, 2 mixed and 1 hepatocellular; resolution in 2-20 weeks, no fatalities; no predictive baseline features identified; another 16% of patients had transient, asymptomatic rises in serum aminotransferase levels during therapy; Case 1).
Woeber KA. (2002). Methimazole-induced hepatotoxicity. Endocr Pract. (36 year old woman developed pruritus and jaundice 3 weeks after starting methimazole [bilirubin 12.1 rising to 25.8 mg/dL, ALT 127 U/L, Alk P 265 U/L], with slow recovery and Alk P abnormalities for ~12 months).
Kontoleon P, Ilias I, Koutras DA, Kontogiannis D, Papapetrou PD. (2002). Successful treatment with carbimazole of a hyperthyroid pregnancy with hepatic impairment after propylthiouracil administration: a case report. Clin Exp Obstet Gynecol. (27 year old woman developed elevations in ALT [151 U/L], with normal bilirubin [0.5 mg/dL] after 12th week of pregnancy while on propylthiouracil, resolving within 10 days of switching to carbimazole).
Ruiz JK, Rossi GV, Vallejos HA, Brenet RW, Lopez IB, Escribano AA. (2003). Fulminant hepatic failure associated with propylthiouracil. Ann Pharmacother. (Two cases: 30 year old woman presented with jaundice 4 months after starting propylthiouracil [bilirubin 29.5 mg/dL, ALT 207 U/L, Alk P 208 U/L, protime 17 sec], with progressive liver failure, sepsis and death within 1 month; 32 year old woman developed jaundice after 5 months of propylthiouracil in 5th month of pregnancy [bilirubin 32.8 mg/dL, ALT 686 U/L, Alk P 364 U/L, protime 19.9 sec], with progressive liver failure, loss of fetus and death of multiorgan failure in 2 months).
Testa G, Trevino J, Bogetti D, Layden T, Wiley T, Sankary H, et al. (2003). Liver transplantation for propylthiouracil-induced acute hepatic failure. Dig Dis Sci. (17 year old girl developed jaundice 7 months after starting propylthiouracil [bilirubin 17.4 mg/dL, ALT 338 U/L, protime 40.8 sec], with progressive hepatic failure requiring liver transplantation).
Russo MV, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug induced liver injury in the United States. Liver Transpl. (Among 2291 liver transplants for acute liver failure done in the US between 1990 and 2002, 357 were attributed to medications, 53% to acetaminophen; in remaining 137 cases, most common agents were isoniazid [24; 17.5%], propylthiouracil [13; 9.5%], phenytoin [10; 7.3%], valproate [10; 7.3%], nitrofurantoin [7; 5%], herbals [7; 5%], ketoconazole [6; 4%] and disulfiram [6; 4%]; none due to methimazole).
Mikhail NE. (2004). Methimazole-induced cholestatic jaundice. South Med J. (43 year old woman developed jaundice and pruritus one month after starting methimazole [bilirubin 16.7 mg/dL, ALT 104 U/L, Alk P 289 U/L], resolving 4 months after discontinuation; review of literature found 20 cases, 18 in women, onset in 3 days to 3 months, largely cholestatic, no fatalities from liver disease, recurrence on rechallenge with methimazole or carbimazole).
Piñero Madrona A, Pons Miñano JA, Madrid Conesa J, Parrilla Paricio P. (2004). Rev Clin Esp. (46 year old woman with subclinical hyperthyroidism developed arthralgias and malaise 6 days after starting methimazole [bilirubin normal, ALT 1280 U/L, Alk P 520 U/L], resolving within 2 weeks of stopping).
Brusco F, González G, Soto N, Arteaga E. (2004). Successful treatment of hyperthyroidism with amiodarone in a patient with propylthiouracil-induced acute hepatic failure. Thyroid. (20 year old woman developed jaundice 4 months after starting propylthiouracil [bilirubin 20.4 mg/dL, ALT 3827 U/L, Alk P 372 U/L, INR 4.4], with hepatic encephalopathy but ultimate recovery over the next several weeks; hyperthyroidism managed with amiodarone until recovery when radioactive iodine was used: Case 3).
Lian XL, Bai Y, Dai WX, Jin ZM, Zeng ZP, Guo ZS. (2004). Zhonghua Nei Ke Za Zhi.
Lian XL, Bai Y, Dai WX, Guo ZS, Li W, Lu L. (2004). Zhongguo Yi Xue Ke Xue Yuan Xue Bao.
Aydemir S, Ustundag Y, Bayraktaroglu T, Tekin IO, Peksoy I, Unal AY. (2005). Fulminant hepatic failure associated with propylthiouracil: a case report with treatment emphasis on the use of plasmapheresis. J Clin Apheresis. (22 year old woman developed jaundice 1.5 years after starting propylthiouracil and 3 weeks after raising the dose to 600 mg daily [bilirubin 26 mg/dL, ALT 1350 U/L, Alk P 266 U/L, protime 69 sec], with slow recovery over 4 months while undergoing multiple courses of plasmapheresis).
Sipe WEB, Su M, Posselt A, Kim GE, Quiros JA, Rosenthal P. (2006). Propylthiouracil-associated liver failure presenting as probable autoimmune hepatitis in a child with Graves' disease. Pediatr Transplant. (7 year old girl developed jaundice 9 months after starting propylthiouracil for Graves disease [bilirubin 7.9 mg/dL, ALT 1634 U/L, Alk P 496 U/L, INR 2.4], with progressive hepatic failure requiring emergency liver transplant 12 days later; ANA positive, but little evidence of improvement with corticosteroids; explant showing massive necrosis).
Casallo Blanco S, Valero MA, Marcos Sánchez F, de Matías Salces L, Blanco González JJ, Martín Barranco MJ. (2007). Gastroenterol Hepatol. (79 year old woman developed jaundice 1 month after starting methimazole [bilirubin 3.2 mg/dL, ALT 184 U/L, Alk P 574 U/L], with prompt improvement on stopping; then, 2 weeks after starting propylthiouracil, she redeveloped jaundice [bilirubin 5.5 mg/dL, ALT 448 U/L, Alk P 279 U/L], these normalizing within 2 months of stopping and with concurrent prednisone therapy).
Benyounes M, Sempoux C, Daumerie C, Rahier J, Geubel AP. (2006). Propylthiouracyl-induced severe liver toxicity: an indication for alanine aminotransferase monitoring?. World J Gastroenterol. (2 cases; 35 year old woman developed jaundice 2-3 months after starting propylthiouracil [bilirubin 10 mg/dL, ALT 1575 U/L], with delayed withdrawal and progressive hepatic failure but ultimate recovery over next 4 months; 43 year old woman developed jaundice 5 months after starting propylthiouracil [bilirubin 10.9 mg/dL, ALT 5040 U/L], improving within 8 weeks of stopping; authors recommend ALT monitoring).
Aycan Z, Arhan E, Cetinkaya E, Vidinlisan S, Menekşe N, Yücel H, et al. (2006). Propylthiouracil-induced hypersensitivity syndrome. Turk J Pediatr. (14 year old girl developed vasculitis 8 months after starting propylthiouracil which progressed on continuing therapy and improved with prednisone and switching to methimazole; no mention of liver involvement).
Ramos-Bonner LS, Goldberg TH, Moyer S, Anastasopoulou C. (2007). Methimazole-induced cholestatic jaundice in an elderly hyperthyroid patient. Am J Geriatr Pharmacother. (76 year old woman developed jaundice and pruritus 6 weeks after starting methimazole [bilirubin 25.4 mg/dL, ALT 676 U/L, Alk P 620 U/L, INR 1.2], worsening for 5 days and then resolving slowly).
Nakamura H, Noh JY, Itoh K, Fukata S, Miyauchi A, Hamada N. (2007). Comparison of methimazole and propylthiouracil in patients with hyperthyroidism caused by Graves' disease. J Clin Endocrinol Metab. (Controlled trial of 2 doses of methimazole vs propylthiouracil in 396 Japanese patients with Graves disease; hepatotoxicity occurred in 27% on propylthiouracil [n=104] vs 6.6% on methimazole [n=267]).
Moral P, Rodríguez Soler M, Mancheño Franch N, Aguilera Sánchez-Tello V, Todolí Parra J, Ponce García J, et al. (2008). Gastroenterol Hepatol. (51 year old man developed jaundice and pruritus [bilirubin 17.9 mg/dL, ALT 92 U/L, Alk P 228 U/L] a few days after restarting propylthiouracil, resolving 2 months after stopping).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Rochon J. (2008). Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to propylthiouracil or methimazole).
Grzywa M, Orłowska-Florek R, Grzywa-Celińska A. (2009). Endokrynol Pol. (Two women, ages 49 and 43, with Graves disease developed jaundice after switching from methimazole to propylthiouracil [bilirubin 17.8 and 35.3 mg/dL, ALT 42 and 82 U/L, Alk P 397 and 232 U/L], both recovering within 2 months of stopping).
Cooper DS, Rivkees SA. (2009). Putting propylthiouracil in perspective. J Clin Endocrinol Metab. (Editorial summarizing issues of hepatotoxicity of propylthiouracil, 33 publications of hepatotoxicity in adults and 14 in children with UNOS reporting 16 liver transplants for acute liver failure due to propylthiouracil in adults and 7 in children between 1990 and 2007. In contrast, methimazole can cause liver injury, but fatalities are rare; these factors led to recommendations that methimazole be used instead of propylthiouracil except in first trimester of pregnancy [or for intolerance] and when surgery or radioiodine are not an option).
Bahn RS, Burch HS, Cooper DS, Garber JF, Greenlee CM, Klein IL, et al. (2009). The role of propylthiouracil in the management of Graves’ disease in adults: report of a meeting jointly sponsored by the American Thyroid Association and the Food and Drug Administration. Thyroid. (The estimated fatality rate from acute liver failure due to propylthiouracil is 1:10,000 and perhaps as high as 1:2000 in children; UNOS has reported 16 deaths in adults and 7 in children since 1990; for these reasons propylthiouracil should not be considered the “first line” of treatment of Graves’ disease, methimazole being preferred except in first trimester of pregnancy).
Rivkees SA, Mattison DR. (2009). Ending propylthiouracil-induced liver failure in children. N Engl J Med. (Letter suggesting that propylthiouracil no longer be used as first line treatment of Graves disease in children, citing high rates of fatal hepatotoxicity from its use).
Rivkees SA, Mattison DR. (2009). Propylthiouracil (PTU) Hepatoxicity in children and recommendations for discontinuation of use. Int J Pediatr Endocrinol. (Review of propylthiouracil induced liver injury; 29 cases reported in literature, 14 in children, 9 resulting in death [3 in children] and 3 in liver transplantation; in contrast, fatality or transplantation due to methimazole induced liver disease has not been reported; concluded that propylthiouracil should not be used as treatment of Graves disease in children).
Gallelli L, Staltari O, Palleria C, De Sarro G, Ferraro M. (2009). Hepatotoxicity induced by methimazole in a previously health patient. Curr Drug Saf. (54 year old man developed fever, rash and then jaundice 14 days after starting methimazole [bilirubin 4.4 mg/dL, ALT 55 U/L, Alk P 374 U/L, GGT 627 U/L], resolving rapidly with stopping methimazole).
Zhang M, Zhou H, He R, Di F, Yang L, Yang T. (2010). Steroids for the treatment of methimazole-induced severe cholestatic jaundice in a 74-year-old woman with type 2 diabetes. Endocrine. (74 year old woman developed jaundice and pruritus 1 month after starting methimazole [bilirubin 14.9 mg/dL, ALT 92 U/L, Alk P 301 U/L], resolving slowly and with 8 weeks of prednisone ).
Livadas S, Xyrafis X, Economou F, Boutzios G, Christou M, Zerva A, Karachalios A, Palioura H, Palimeri S, Diamanti-Kandarakis E. (2010). Liver failure due to antithyroid drugs: report of a case and literature review. Endocrine. (34 year old woman developed pruritus 20 days after starting methimazole [bilirubin 2.4 rising to 3.6 mg/dL, ALT 141 to 1125 U/L, Alk P 189 to 396 U/L], resolving within 4 weeks of stopping).
Shen C, Zhao CY, Liu F, Wang YD, Yu J. (2010). Acute-on-chronic liver failure due to thiamazole in a patient with hyperthyroidism and trilogy of Fallot: case report. BMC Gastroenterol. (24 year old man developed jaundice 1 year after starting methimazole [bilirubin 34.3 mg/dL, ALT 75 U/L, Alk P 133 U/L, INR 2.3], with progression to hepatic failure and death 27 days after presentation).
Alvarez MP, Cano RL, Fernández CP, Méndez LF, García RG. (2010). Endocrinol Nutr. (Two cases; 71 and 52 year old women developed enzyme elevations 6 weeks after starting methimazole [bilirubin 0.8 and 0.9 mg/dL, ALT 102 and 546 U/L, Alk P 889 and 999 U/L], resolving within 2 and 4 months of stopping).
Rivkees SA, Szarfman A. (2010). Dissimilar hepatotoxicity profiles of propylthiouracil and methimazole in children. J Clin Endocrinol Metab. (Analysis of FDA adverse event reports between 1969 and 2008 showed a higher rate of severe liver injury due to propylthiouracil than methimazole in children; “We are unaware of reports of death and liver failure in children and adolescents taking methimazole”).
Malozowski S, Chiesa A. (2010). Propylthiouracil-induced hepatotoxicity and death. Hopefully, never more. J Clin Endocrinol Metab. (Editorial in response to Rivkees [2010] summarizing the factors that led to the recommendation that propylthiouracil be avoided in children and be considered a second line drug for treating hyperthyroidism in adults).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, neither propylthiouracil or methimazole were listed in the top 41 causes).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 5 were attributed to propylthiouracil, none to methimazole).
Carrion AF, Czul F, Arosemena LR, Selvaggi G, Garcia MT, Tekin A, Tzakis AG, et al. (2010). Propylthiouracil-induced acute liver failure: role of liver transplantation. Int J Endocrinol. (Two women; one 29 year old developed ALT elevations 4 weeks and jaundice 10 weeks after starting propylthiouracil [bilirubin 19.3 mg/dL, ALT443 U/L, Alk P 509 U/L, INR 3.9], undergoing liver transplantation 8 days later; 34 year old developed jaundice 6 weeks after starting propylthiouracil [bilirubin 12.8 mg/dL, ALT 1227 U/L, Alk P 272 U/L, INR 4.3], undergoing transplant 5 days later).
Rivkees SA. 63 years and 715 days to the "boxed warning": unmasking of the propylthiouracil problem. Int J Pediatr Endocrinol. 2010; 2010. doi:pii: 658267. (History of the debate on the safety of propylthiouracil that led to the FDA boxed warning and recommendation that methimazole be the first line drug for hyperthyroidism, particularly in children).
Koch L. (2010). Therapy: Propylthiouracil use associated with severe hepatotoxicity in children. Nat Rev Endocrinol. (Editorial comment on Rivkees [2010]).
Primeggia J, Lewis JH. (2010). Gone (from the Physicians' desk reference) but not forgotten: propylthiouracil-associated hepatic failure: a call for liver test monitoring. J Natl Med Assoc. (19 year old girl with Graves disease developed jaundice 3 months after starting propylthiouracil [bilirubin 6.5 mg/dL, ALT 1589 U/L, INR 3.0], with progressive liver failure and unsuccessful liver transplant 2 weeks after presentation).
Regelmann MO, Miloh T, Arnon R, Morotti R, Kerkar N, Rapaport R. (2012). Graves disease presenting with severe cholestasis. Thyroid. (17 year old girl with acute hepatitis A and Graves disease developed marked cholestasis, which improved with therapy of hyperthyroidism).
Sato H, Minagawa M, Sasaki N, Sugihara S, Kazukawa I, Minamitani K, Wataki K, et al. (2011). Comparison of methimazole and propylthiouracil in the management of children and adolescents with Graves' disease: efficacy and adverse reactions during initial treatment and long-term outcome. J Pediatr Endocrinol Metab. (Retrospective analysis of safety and efficacy of methimazole in 64 and propylthiouracil in 69 children with hyperthyroidism found similar response rates, but more frequent adverse events with initial high doses of propylthiouracil).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-Induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN Prospective Study. J Pediatr Gastroenterol Nutr. (Among 30 children with drug induced liver injury enrolled in a prospective US database between 2004 and 2008, none were attributed to propylthiouracil or methimazole).
Sequeira E, Wanyonyi S, Dodia R. (2011). Severe propylthiouracil-induced hepatotoxicity in pregnancy managed successfully by liver transplantation: A case report. J Med Case Rep. (36 year old pregnant woman developed Graves disease at 7 weeks gestation and jaundice at 17 weeks, 7 weeks after starting propylthiouracil [no liver test results provided], leading to liver transplantation and thyroidectomy, and Cesarean section at 37 weeks with delivery of a child with microcephaly).
Sato I, Tsunekawa T, Shinohara Y, Nishio Y, Shimizu Y, Suzuki Y, Yoshioka S. (2011). A case of autoimmune hepatitis with Graves' disease treated by propylthiouracil. Nagoya J Med Sci. (58 year old woman developed ALT elevations 18 months after starting propylthiouracil that resolved on stopping, but recurred on restarting [bilirubin not provided, ALT 619 U/L, Alk P 445 U/L, ANA positive, IgG 2877 mg/dL], a biopsy suggested autoimmune hepatitis and she improved on prednisone therapy, but no information on outcome).
Hackmon R, Blichowski M, Koren G. (2012). The safety of methimazole and propylthiouracil in pregnancy: a systematic review. J Obstet Gynaecol Can. (Systematic review of the safety of propylthiouracil and methimazole during pregnancy concludes that propylthiouracil "has been associated with a rare, but serious form of hepatic failure").
Karras S, Memi E, Kintiraki E, Krassas GE. (2012). Pathogenesis of propylthiouracil-related hepatotoxicity in children: present concepts. J Pediatr Endocrinol Metab. (Review of the mechanism of action of propylthiouracil and current concepts of the pathogenesis of its hepatotoxicity).
Glinoer D, Cooper DS. (2012). The propylthiouracil dilemma. Curr Opin Endocrinol Diabetes Obes. (Review of FDA reports from 1982 to 2008 found 13 cases of hepatic failure due to propylthiouracil in children and 28 in adults; risk factors were longer duration of therapy, higher doses, pediatrics, female sex and potentially black race).
Otsuka F, Noh JY, Chino T, Shimizu T, Mukasa K, Ito K, Ito K, Taniyama M. (2012). Hepatotoxicity and cutaneous reactions after antithyroid drug administration. Clin Endocrinol (Oxf). (Among 391 patients with hyperthyroidism, ALT levels >2 times ULN occurred in 9% on methimazole vs 26% on propylthiouracil arising after 12 to 60 days, but "...no serious liver failure was observed").
Kwon H, Lee SH, Kim SE, Lee JH, Jee YK, Kang HR, Park BJ, Park JW, Hong CS. (2012). Spontaneously reported hepatic adverse drug events in Korea: multicenter study. J Korean Med Sci. (Summary of 2 years of adverse event reporting in Korea; of 9360 reports, 567 were liver related, including two attributed to propylthiouracil).
de Campos Mazo DF, de Vasconcelos GB, Pereira MA, de Mello ES, Bacchella T, Carrilho FJ, et al. (2013). Clinical spectrum and therapeutic approach to hepatocellular injury in patients with hyperthyroidism. Clin Exp Gastroenterol. (Among 7 patients with hyperthyroidism found to have liver disease, 2 were attributed to propylthiouracil hepatotoxicity, 2 to autoimmune hepatitis and 3 to the underlying hyperthyroidism).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to antithyroid medications).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, five [including 2 deaths] were attributed to propylthiouracil but none to methimazole).
Wang MT, Lee WJ, Huang TY, Chu CL, Hsieh CH. (2014). Antithyroid drug-related hepatotoxicity in hyperthyroidism patients: a population-based cohort study. Br J Clin Pharmacol. (Among 71,379 patients with hyperthyroidism initiating medical therapy between 2004 and 2009 identified in the Taiwanese National Health Insurance Research Database, methimazole/carbimazole had a higher rate of clinically apparent liver injury than propylthiouracil [3.2 vs 1.2] but a lower rate of acute liver failure [0.32 vs o.68: both per 1000-patient years]).
Akmal A, Kung J. (2014). Propylthiouracil, and methimazole, and carbimazole-related hepatotoxicity. Expert Opin Drug Saf. (Review of the hepatotoxicity of antithyroid medications concludes that methimazole and carbimazole are more likely to cause cholestatic liver injury, while propylthiouracil is more likely to cause acute liver failure for which reason its use should be limited to use in adults and in the first trimester of pregnancy and thyroid storm).
Heidari R, Niknahad H, Jamshidzadeh A, Abdoli N. (2014). Factors affecting drug-induced liver injury: antithyroid drugs as instances. Clin Mol Hepatol. (Review of risk factors associated with liver injury from methimazole and propylthiouracil including age, gender, alcohol use and co-morbidities, none of which appear to play a very major role).
Heidari R, Niknahad H, Jamshidzadeh A, Eghbal MA, Abdoli N. (2015). An overview on the proposed mechanisms of antithyroid drugs-induced liver injury. Adv Pharm Bull. (Review of the possible mechanisms of liver injury due to methimazole and propylthiouracil).
Papachristos DA, Huynh J, Grossman M, MacIsaac RJ. Liver dysfunction and anti-thyroid therapy. SAGE Open Med Case Rep 2015; 3: 2050313X14568335. (49 year old man with Graves disease developed jaundice 2 weeks after starting carbimazole [bilirubin 34 mg/dL, ALT 104 U/L, Alk P 147 U/L], which resolved within 3 months of stopping and after radioactive iodine treatment making it difficult to assess whether the injury was due to the medication versus hyperthyroidism).
Yang J, Li LF, Xu Q, Zhang J, Weng WW, Zhu YJ, Dong MJ. (2015). Analysis of 90 cases of antithyroid drug-induced severe hepatotoxicity over 13 years in China. Thyroid. (Among 90 patients with hyperthyroidism and drug induced liver injury due to antithyroid therapy seen at a single medical center over a 13 year period, 51 were attributed to methimazole [1 fatal] and 39 to propylthiouracil [none fatal]; both had similar latencies to onset [80% within 3 months, 60% within 1 month] and methimazole cases were more likely to be cholestatic [35% vs 18%] and less likely hepatocellular [43% vs 56%]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 [0.7%] were attributed to antithyroid drugs including 3 to methimazole [thiamazole] all of which were cholestatic or mixed and self-limited in course, and 3 to propylthiouracil, one of which was fatal and one occurring in a woman treated during pregnancy).
Čalkić L, Bajramović-Omeragić L. (2017). Relationship of recovered hepatitis B infection with appearance of toxic propylthiouracil hepatitis. Med Glas (Zenica). (45 year old woman with hyperthyroidism and anti-HBc without HBsAg in serum developed jaundice after switching from methimazole to propylthiouracil [bilirubin 8.8 rising to 16.2 mg/dL, ALT 570 U/L, Alk P 217 U/L], ultimately recovering, with no change in hepatitis B serology).
Wu DB, Chen EQ, Bai L, Tang H. (2017). Propylthiouracil-induced liver failure and artificial liver support systems: a case report and review of the literature. Ther Clin Risk Manag. (16 year old Chinese girl developed jaundice 5 months after starting propylthiouracil for Graves disease [bilirubin 25.8 mg/dL, ALT 130 U/L, Alk P normal, INR 2.35] and was treated with 4 sessions of an artificial liver support system which was associated with a decrease in bilirubin, ALT, bile acids and ammonia levels each time and was followed by clinical recovery).
Suzuki N, Noh JY, Hiruma M, Kawaguchi A, Morisaki M, Ohye H, Suzuki M, et al. (2019). Analysis of antithyroid drug-induced severe liver injury in 18,558 newly diagnosed patients with Graves' disease in Japan. Thyroid. (Among 18,558 Japanese patients initiating medical therapy of Graves disease between 2005 and 2017, 416 [2.5%] developed evidence of liver injury [ALT above 8 times ULN or bilirubin above 3 times ULN], 1.4% on methimazole and 6.3% of propylthiouracil, 92% were women, onset usually within 30 days, rates being age-dependent and all patients recovered).

## OTHER REFERENCE LINKS

1 Recent References on Propylthiouracil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(propylthiouracil/AE)+AND+Human%5BMH%5D+AND+(durg+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/2/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Propylthiouracil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=propylthiouracil)